# Finasteride

## OVERVIEW

### Introduction

Finasteride is a 5-alpha reductase inhibitor used to treat symptoms of benign prostatic hypertrophy and male pattern baldness. Finasteride is associated with a low rate of transient serum aminotransferase elevations, but has yet to be linked to instances of clinically apparent, acute liver injury.

### Background

Finasteride (fin as' ter ide) was the first 5-alpha reductase inhibitor to be approved for use as therapy of symptomatic benign prostatic hypertrophy in the United States. Finasteride inhibits the steroid 5-alpha reductase, which blocks the conversion of testosterone to dihydrotestosterone, a form of the androgenic hormone that is important in the development and maintenance of prostatic hyperplasia. Serum dihydrotesterone levels are decreased by 70% to 90% by finasteride therapy with little effect on testosterone levels. Finasteride takes several months to have an effect on prostate size and symptoms of prostatic hypertrophy (urinary hesitancy and poor stream), unlike the alpha-1 adrenergic receptor blockers which have a more immediate effect. Finasteride also inhibits the steroid 5-alpha reductase present in skin, which led to its use in the therapy or prevention of male pattern baldness. Finasteride was approved for use in the United States in 1992 and is available in 5 mg tablets generically and under the trade name Proscar for prostatic hypertrophy, and as 1 mg tablets under the name Propecia for male pattern baldness. The recommended dose for therapy of prostatic hypertrophy is 5 mg once daily, and it generally requires 3 to 6 months before an effect is obtained and thereafter requires long term therapy. The dose of finasteride for male pattern baldness is 1 mg daily. It is not recommended as therapy for baldness in women. Side effects are uncommon, but include a low rate of impotence and decreased libido, gynecomastia, dizziness and weakness. Finasteride also decreases serum PSA levels (~50%), which should be monitored during therapy.

### Hepatotoxicity

Finasteride has been associated with a low rate of serum aminotransferase elevations that, in controlled trials, was no higher than with placebo therapy. These elevations were transient and rarely required dose modification, and have occurred with both the 5 mg dose for prostatic hypertrophy and the 1 mg dose for hair growth. There have been published reports of transient serum enzyme elevations occurring during finasteride therapy, but none of clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver injury associated with finasteride is not known. Finasteride is an azosteroid and is extensively metabolized in the liver via the cytochrome P450 system (CYP 3A4) and a relatively toxic intermediate might cause the mild serum enzyme elevations that can occur with therapy.

References on the safety and potential hepatotoxicity of finasteride are given in the Overview section on the 5-Alpha Reductase Inhibitors.

Drug Class: Benign Prostatic Hypertrophy Agents, 5-Alpha Reductase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Finasteride – Generic, Proscar®

DRUG CLASS

Benign Prostatic Hypertrophy Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Finasteride)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Finasteride | 98319-26-7 | C23-H36-N2-O2 | Finasteride Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Finasteride: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Finasteride/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Finasteride: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Finasteride)